# Isotretinoin

## OVERVIEW

### Introduction

Isotretinoin is a retinoid and vitamin A derivative used in the treatment of severe acne and some forms of skin, head and neck cancer. Isotretinoin, like many retinoids, can lead to increase in serum aminotransferase levels, but, unlike acitretin and etretinate, isotretinoin has not been clearly implicated in cases of clinically apparent acute liver injury with jaundice.

### Background

Isotretinoin (eye" soe tret' i noyn), also known as 13-cis-retinoic acid, is an aromatic retinoid similar to vitamin A which is effective in treating refractory nodular acne and other disorders of keratinization. Unlike vitamin A, isotretinoin is not stored in the liver and is not associated with many of the toxic effects of high dose vitamin A therapy. Its mechanism of action in acne is believed to be mediated by activation of retinoic acid and retinoid X receptors, which regulate gene expression important in normalizing cell growth and differentiation. Isotretinoin is considered a second generation retinoid and its relative lack of receptor specificity accounts for its adverse side effects. All oral retinoids are potent teratogens and must be avoided or used with extreme caution in women of childbearing potential. Isotretinoin was approved for use in acne in the United States in 1982 and it is currently used, but only under strict requirements for monitoring and birth control. Indications are limited to severe nodular acne in a patient who has failed to respond to conventional therapy including systemic antibiotics. Isotretinoin is available in generic forms and under several brand names (Absorica, Amnesteem, Claravis, Myorisan, Sotret, Zenatane and previously Accutane) in capsules of 10, 20, 30 and 40 mg, the usual dose in adults being 0.5 to 2.0 mg/kg per day given in two divided doses for 15 to 20 weeks. Higher doses have been used in treatment of head and neck cancers. Side effects are common and include dry skin, nose bleeds, conjunctivitis and hair loss. Use of isotretinoin has also been linked to worsening of hyperlipidemia, hyperostosis, vision and hearing loss, pancreatitis, pseudotumor cerebri, birth defects, depression and suicide.

### Hepatotoxicity

Liver test abnormalities occur in up to 15% of patients on isotretinoin, although marked elevations above three times the upper limit of normal or requiring drug discontinuation are rare (<1%). The liver test abnormalities are typically asymptomatic and transient and can resolve even with continuing therapy. Clinically apparent liver injury due to isotretinoin is exceedingly rare. The acute liver injury with signs of hypersensitivity that occurs with etretinate and acitretin has not been described with isotretinoin therapy. Vitamin A-like effects on the liver with accumulation of lipids in nonparenchymal stellate cells has been described in rare patients on isotretinoin therapy, but the role of supplementary use of vitamin A in these cases was not ruled out. Thus, the majority of reported cases of liver injury attributed to isotretinoin have been anicteric with no or minimal symptoms. However, the lack of reports of more severe hepatitis with jaundice may be due to the close monitoring and early discontinuation of isotretinoin which is required in the use of this agent for acne.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which isotretinoin causes serum aminotransferase elevations is not known, but it may represent a direct toxic effect, in that it appears to be more frequent with higher dose therapy.

### Outcome and Management

Monitoring of liver tests is recommended for patients receiving isotretinoin at regular intervals. The serum aminotransferase elevations that occur during treatment are usually self-limited and do not always require dose modification or discontinuation of therapy. However, de novo elevations in serum aminotransferase levels of more than 5 times the upper limit of normal should prompt at least temporary discontinuation, particularly if confirmed on a second sample or if accompanied by symptoms or jaundice. Patients with acitretin or etretinate associated acute liver injury have been found to tolerate isotretinoin without recurrence of liver injury, although isotretinoin is not approved and may not be as effective as acitretin in treating psoriasis.

Drug Class: Dermatologic Agents; Vitamins

Other Drugs in the Subclass:

- Vitamin A
- Retinoids
  - Acitretin, Etretinate
  - Bexarotene

## CASE REPORT

### Case 1. Acute anicteric hepatitis with autoimmune features due to isotretinoin.(1)

A 16 year old adolescent female was found to have serum aminotransferase elevations 11 weeks after starting isotretinoin for severe acne. She had no history of liver disease, drug allergies, risk factors for viral hepatitis or alcohol use. Her past medical history included Hashimoto thyroiditis and hypothyroidism for which she took levothyroxine (50 mg daily). She was taking no other medications including over-the-counter products and herbal supplements. She had no symptoms of liver disease and the elevations were identified during routine monitoring of the isotretinoin therapy. Physical examination showed no evidence of hepatomegaly, abdominal tenderness or jaundice. Laboratory tests showed a serum ALT of 853 [22.4 times ULN], AST 501 U/L [12.5 times ULN], alkaline phosphatase 48 U/L [normal <340], and bilirubin 0.3 mg/dL [direct 0.10]. The R ratio was 22. The following week the ALT had risen to 1199 U/L and AST to 756 U/L, and isotretinoin was stopped (Table). Serum bilirubin remained normal, albumin was 4.3 g/dL, globulins 2.9 g/dL and INR 1.1. Tests for hepatitis A, B, C and E were negative. While serum SMA was negative, ANA was positive in a titer of 1:160 and IgG was mildly elevated [1659 mg/dL, normal 700-1550 mg/dL]. Abdominal ultrasonography showed no evidence of biliary obstruction and no organomegaly or hepatic masses. A liver biopsy showed focal hepatocyte degeneration and parenchymal lymphocytic infiltration as well as mild portal inflammation and mild interface hepatitis. Because of the possibility of autoimmune hepatitis, she was started on prednisone (40 mg daily) to which azathioprine was added 2 weeks later. The serum aminotransferase levels rapidly improved and were normal 6 weeks after starting therapy. The prednisone was gradually reduced in dosage and eventually discontinued. The liver tests remained normal thereafter; isotretinoin was not restarted.

#### Key Points

Medication: | Isotretinoin (20 mg twice daily)
Pattern: | Hepatocellular (peak R=32)
Severity: | 1+ (anicteric)
Latency: | 11 weeks
Recovery: | 8 weeks
Other medications: | Levothyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Pre | 0 | 26 | 43 | 0.4 | Isotretinoin started
11 weeks | 0 | 853 | 48 | 0.3 | Asymptomatic
12 weeks | 0 | 1199 | 114 | 0.4 | Isotretinoin stopped
14 weeks | 2 weeks | 327 | 105 | 0.3 | Prednisone 40 mg/d
15 weeks | 3 weeks | 123 | 78 | 0.3 | Azathioprine added
17 weeks | 5 weeks | 68 | 52 | 0.3 | Prednisone dose reduced
19 weeks | 7 weeks | 41 | 29 | 0.3
5 months | 2 months | 40 | 23 | 0.4 | Prednisone 5 mg/d
6 months | 3 months | 24 | 19 | 0.3
1.5 years | 1 year | 23 | 41 | 0.7 | No Pred or Azathioprine
2 years | 2 years | 16 | 40 | 0.4
3 years | 3 years | 25 | 31 | 0.4
Normal Values | | <38 | <340 | <1.2

#### Comment

An acute anicteric hepatitis arose during isotretinoin therapy in an adolescent girl with acne and a history of autoimmune thyroid disease. The hepatitis was asymptomatic, but ALT levels rose to 32 times ULN and the drug was stopped. Testing revealed a high titer of ANA and mild immunoglobulin elevations prompting a liver biopsy that was read as compatible with autoimmune hepatitis. She was treated with prednisone and azathioprine and liver tests fell to normal within 6 to 8 weeks. The dose of prednisone was gradually decreased and both prednisone and azathioprine were subsequently discontinued. She was followed carefully thereafter, and liver tests remained normal. This case nicely demonstrates the marked serum aminotransferase elevations that can occur during isotretinoin therapy. Unique in this case was the accompanying autoimmune features which led to use of immunosuppression. Importantly, prednisone and azathioprine were subsequently reduced in dose and then discontinued. Liver tests remained normal indicating that the injury was probably drug induced liver injury with autoimmune features rather than spontaneous autoimmune hepatitis. [Addition details and test results kindly provided by Dr. Patricia Guzman.]

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Isotretinoin – Generic, Absorica®, Claravis®, Zenatane®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Isotretinoin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Isotretinoin | 4759-48-2 | C20-H28-O2 | [image]

## CITED REFERENCES

1 Guzman Rojas P, Gallegos Lopez R, Ciliotta Chehade A, Scavino Y, Morales A, Tagle M. (2016). Rev Gastroenterol Peru.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 November 2020

Zimmerman HJ. Vitamin A(retinol). Drugs used in dermatotherapy. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 727-9. (Expert review of hepatotoxicity of vitamin A and the retinoids published in 1999; mentions two published reports of acute necrosis due to acitretin).
Liu LU, Schiano TD. Vitamin A (retinol). Hepatotoxicity of herbal medications, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 744-6. (Review of vitamin A and retinoid hepatotoxicity published in 2007).
Sewell MJ, Burkhart C, Morrell D. Dermatological pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1271-96. (Textbook of pharmacology and therapeutics).
Peck GL, Olsen TG, Yoder FW, Strauss JS, Downing DT, Pandya M, Butkus D, et al. (1979). Prolonged remissions of cystic and conglobate acne with 13-cis-retinoic acid. N Engl J Med. (Initial report on use of isotretinoin for severe acne mentions that mild and transient ALT elevations occurred in one of the 14 patients treated for 4 months).
Thune P, Mork NJ. (1980). A case of centrolobular toxic necrosis of the liver due to aromatic retinoid--Tigason (Ro-10-9359). Dermatologica. (54 year old woman with ichthyosis developed fatigue 2-3 months after starting etretinate [peak bilirubin 2.6 mg/dL, ALT 1260 U/L, Alk P 350 U/L], biopsy showing centrolobular necrosis, with slow resolution over the next 6 months).
Peck GL, Olsen TG, Butkus D, Pandya M, Arnaud-Battandier J, Gross EG, Windhorst DB, et al. (1982). Isotretinoin versus placebo in the treatment of cystic acne. A randomized double-blind study. J Am Acad Dermatol. (Controlled trial of 4 months of isotretinoin in 33 patients with severe acne showed dramatic therapeutic effect; side effects were dry skin, eyes and nasal membranes and dermatitis; ALT elevations occurred in 3 patients [10%], but levels returned to normal despite continuing and no patient stopped therapy because of side effects).
Olson JA. (1983). Adverse effects of large doses of vitamin A and retinoids. Semin Oncol. (Review of retinoids and vitamin A which do not share same toxicity, but usually have a low therapeutic-toxic index).
Hennes R, Mack A, Schell H, Vogt HJ. (1984). 13-cis-retinoic acid in conglobate acne. A follow-up study of 14 trial centers. Arch Dermatol Res. (Among 87 patients treated with isotretinoin for severe acne monitored for 12-21 months, sustained remissions occurred in 81% and all side effects resolved within 3 months of stopping; no mention of hepatotoxicity).
Ward A, Brogden RN, Heel RC, Speight TM, Avery GS. (1984). Isotretinoin. A review of its pharmacological properties and therapeutic efficacy in acne and other skin disorders. Drugs. (Review of pharmacology, efficacy and safety of isotretinoin: elevations in liver tests occur in 10% of patients, "although these changes rarely reach statistical or clinical significant levels").
Marsden JR, Trinick TR, Laker MF, Shuster S. (1984). Effects of isotretinoin on serum lipids and lipoproteins, liver and thyroid function. Clin Chim Acta. (7 patients with rosacea were treated with isotretinoin for 16 weeks; average serum AST levels increased from 17 to 24 U/L and Alk P from 69 to 81 U/L, while bilirubin levels fell and no patient developed clinically apparent liver injury).
Strauss JS, Rapini RP, Shalita AR, Konecky E, Pochi PE, Comite H, Exner JH. (1984). Isotretinoin therapy for acne: results of a multicenter dose-response study. J Am Acad Dermatol. (150 patients with nodulocystic acne were treated with one of 3 doses of isotretinoin [0.1, 0.5 or 1.0 mg/kg/day] for 20 weeks; side effects were common [dry skin, nosebleeds, hair loss, headache], mean ALT and AST values increased slightly in the highest dose group, and AST increases occurred in 15-18% of patients, but did not lead to dose modification or clinical symptoms).
Heller EH, Shiffman NJ. (1985). Synthetic retinoids in dermatology. Can Med Assoc J. (Discussion of two synthetic analogues of vitamin A introduced into dermatology: isotretinoin [used in acne] and etretinate [used in psoriasis]; these retinoids are less toxic than vitamin A and not stored in the liver, although they are metabolized there; minor liver test abnormalities may arise during therapy, but rarely required dose modification).
Vahlquist A. (1985). LöL, Nordlinder H, Rollman O, Vahlquist C. Differential hepatotoxicity of two oral retinoids (etretinate and isotretinoin) in a patient with palmoplantar psoriasis. Acta Derm Venereol. (64 year old woman was found to have abnormal liver tests 5 months after starting etretinate [bilirubin 0.7 mg/dL, ALT 950 U/L, Alk P 402 U/L], liver biopsy showing hepatitis without steatosis, resolving with stopping and prednisone therapy, recurring upon rechallenge, but not when isotretinoin was started which was less effective for the psoriasis).
Yob EH, Pochi PE. (1987). Side effects and long-term toxicity of synthetic retinoids. Arch Dermatol. (Retinoids are modifications of vitamin A molecule and are not stored in the liver; hepatotoxicity of retinoids is different from that of vitamin A, usually arising within first 1-2 months and having features of hypersensitivity).
David M, Hodak E, Lowe NJ. (1988). Adverse effects of retinoids. Med Toxicol Adverse Drug Exp. (Review of pharmacology, clinical effectiveness and low dose, long term toxicities of the retinoids; states that therapy usually has little effect on ALT or bilirubin levels).
Roenigk HH. (1988). Liver toxicity of retinoid therapy. J Am Acad Dermatol. (Review of hepatotoxicity of vitamin A and the retinoids).
Roenigk HH. (1989). Liver toxicity of retinoid therapy. Pharmacol Ther. (Review of toxicity of retinoids including description of liver biopsy results described by Glazer [1982]).
Fallon MB, Boyer JL. (1990). Hepatic toxicity of vitamin A and synthetic retinoids. J Gastroenterol Hepatol. (Review of liver injury due to hypervitaminosis A and retinoids identified 18 reports of vitamin A hepatotoxicity in the English literature, patient ages 6 to 63 years, presenting with rash, fatigue, hepatomegaly and hepatic synthetic dysfunction, biopsy showing fat in stellate cells and fibrosis; little evidence that isotretinoin causes liver injury other than mild rapidly reversible ALT elevations; etretinate causes ALT elevations in ~20% of patients and case reports of clinically apparent injury have been published, but vary in clinical patterns).
Marhold I, Duschet P, Schwarz T, Gschnait F. (1991). Hautarzt. (29 year old woman with psoriasis responded to etretinate but developed rising Alk P levels [172 to 1736 U/L] without jaundice and only mild ALT increases [38 to 178 U/L] 24 days after starting therapy, which improved on stopping and she later tolerated isotretinoin without recurrence [Alk P 118 U/L, ALT 14 U/L]).
Taylor AE, Mitchison H. (1991). Fatty liver following isotretinoin therapy. Br J Dermatol. (18 year old male body builder developed elevated ALT levels [134 U/L] without jaundice during 6 month course of isotretinoin for acne; liver biopsy showed marked steatosis, but ALT levels remained high 20 months after stopping drug).
McElwee NE, Schumacher MC, Johnson SC, Weir TW, Greene SL, Scotvold MJ, Hunter JR, et al. (1991). An observational study of isotretinoin recipients treated for acne in a health maintenance organization. Arch Dermatol. (Retrospective analysis of 466 patients treated with isotretinoin in a health care maintenance organization found 6 [1.8%] with moderate AST elevations [90-350 U/L], but levels often normalized despite drug continuation; isotretinoin stopped in 3 patients for liver tests abnormalities).
Vahlquist A. (1992). Long-term safety of retinoid therapy. J Am Acad Dermatol. (Patients have been treated with retinoids for up to 15 years, generally without toxicity; retinoids do not accumulate in the liver and do not cause accumulation of fat droplets in stellate cells as occurs with hypervitaminosis A; two types of hepatotoxicity, one idiosyncratic acute hepatitis typically occurring with aromatic retinoids and one a long term low grade injury that can lead to cirrhosis, perhaps aggravated by alcohol that the author claims can occur with all retinoids).
Barth JH, Macdonald-Hull SP, Mark J, Jones RG, Cunliffe WJ. (1993). Isotretinoin therapy for acne vulgaris: a re-evaluation of the need for measurements of plasma lipids and liver function tests. Br J Dermatol. (Retrospective analysis of 209 patients treated with isotretinoin found "no significant change in any of the tests of liver function", which led the authors to argue against the recommendation for routine monitoring of liver tests during therapy).
Gunston G, Mehta U, van de Wal B. (1998). New warnings on the use of isotretinoin (Roaccutane). S Afr Med J. (Summary of warnings placed on isotretinoin regarding suicide and potential of liver test abnormalities; 15% of patients on therapy had some degree of liver test abnormality arising on therapy, mostly asymptomatic and resolving without altering dose).
Mawson AR, Steele TA. (2001). Possible role of retinoids in hepatitis B virus-associated liver damage. Exp Biol Med (Maywood). (Review and hypothesis regarding interactions of vitamin A, retinoids and hepatitis B virus infection).
McLane J. (2001). Analysis of common side effects of isotretinoin. J Am Acad Dermatol. (Prospective analysis of safety in two trials of isotretinoin in 369 patients with acne found no overall change in mean ALT levels "to a significant extent" and no episodes of hepatitis and jaundice; no mention of drug discontinuation for ALT elevations).
Alcalay J, Landau M, Zucker A. (2001). Analysis of laboratory data in acne patients treated with isotretinoin: is there really a need to perform routine laboratory tests?. J Dermatolog Treat. (Retrospective analysis of computerized medical files from 1292 patients treated with isotretinoin for 5 to 9 months, found no patient who required discontinuation because of liver tests; elevations occurred in a "minority of patients", with peak ALT levels of 40-240 U/L).
Charakida A, Mouser PE, Chu AC. (2004). Safety and side effects of the acne drug, oral isotretinoin. Expert Opin Drug Saf. (Review of myriad of toxicities of isotretinoin from clinical trials: approximately 15% of patients have mild-to-moderate liver test abnormalities, although frank hepatotoxicity is "a fairly rare event").
Amichai B, Shemer A, Grunwald MH. (2006). Low-dose isotretinoin in the treatment of acne vulgaris. J Am Acad Dermatol. (Among 638 patients with moderate acne treated with isotretinoin, improvement in >90%; 5% had ALT elevations [all less than 2 times ULN]; no mention of jaundice, symptomatic hepatitis or dose modification because of liver test abnormalities).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one was attributed to acitretin: Case 1 for acitretin).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, isotretinoin was the most frequently mentioned agent [420 cases: 6.4%], but no information on the characteristics of the cases is provided).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, no cases were attributed to vitamin A or retinoids).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to vitamin A or a retinoid).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of the hepatotoxicity of herbals and nutritional supplements including vitamin A, toxic levels being above 50,000 IU daily, but toxic dose is lower in persons with risk factors such as underlying liver disease).
Vieira AS, Beijamini V, Melchiors AC. (2012). The effect of isotretinoin on triglycerides and liver aminotransferases. An Bras Dermatol. (Among 70 patients treated with isotretinoin for 4-12 months, mean serum ALT levels increased from 18 to 23 U/L, but no mention of clinically apparent liver injury or discontinuations).
Tripathi SV, Gustafson CJ, Huang KE, Feldman SR. (2013). Side effects of common acne treatments. Expert Opin Drug Saf. (Review of side effects of acne treatments including isotretinoin mentioning that it can cause hepatitis, for which reason monitoring of aminotransferase levels is recommended).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, three of which were attributed to isotretinoin [ranking 6th in frequency] all of which were anicteric and only one symptomatic).
Blasiak RC, Stamey CR, Burkhart CN, Lugo-Somolinos A, Morrell DS. (2013). High-dose isotretinoin treatment and the rate of retrial, relapse, and adverse effects in patients with acne vulgaris. JAMA Dermatol. (Among 116 patients with severe acne treated with isotretinoin, ALT levels above 105 U/L arose in only 1 patient).
Kızılyel O, Metin MS, Elmas ÖF, Çayır Y, Aktaş A. (2014). Effects of oral isotretinoin on lipids and liver enzymes in acne patients. Cutis. (In a retrospective analysis of 320 patients with acne treated with isotretinoin for up to 6 months, average ALT levels increased, but the change was not statistically significant).
Fernández-Crehuet P, Fernández-Crehuet JL, Allam MF, Fernández-Crehuet Navajas R. (2014). Hepatotoxicity of isotretinoin in patients with acne and Gilbert's syndrome: a comparative study. BMJ Open. (Among 37 patients with acne treated with isotretinoin for up to 20 weeks, serum bilirubin and ALT levels did not worsen, bilirubin levels actually falling in 11 patients with Gilbert's syndrome).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, two of which were attributed to retinoids, unclear which ones).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 cases were attributed to acitretin, but none to other retinoids or vitamin A).
Homma Y, Otani N, Ishimatsu S. (2015). A case report of acute vitamin A intoxication due to ocean perch liver ingestion. J Emerg Med. (27 year old man developed flushing, headache, nausea and joint pains one day after eating 800 g of ocean perch liver, with normal liver enzymes, but high retinol levels and subsequent facial desquamation).
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. (2015). Invest Clin. (During a one year period, 13 cases of drug induced liver injury were seen at a single hospital in Venezuela, the implicated agents being acetaminophen [3], ibuprofen [3], isoniazid [2], Herbalife products [2: one fatal], and 1 each of isotretinoin, amoxicillin/clavulanate and methotrexate).
Ahmad HM. (2015). Analysis of clinical efficacy, side effects, and laboratory changes among patients with acne vulgaris receiving single versus twice daily dose of oral isotretinoin. Dermatol Ther. (Among 58 patients with acne treated with isotretinoin for an average of 22 weeks, ALT levels increased by 21% with once daily and 3% with twice daily administration of the same average dose, but all elevations were transient and less than 100 U/L).
Bugdayci G, Polat M, Oguzman H, Cinpolat HY. (2016). Interpretation of biochemical tests using the reference change value in monitoring adverse effects of oral isotretinoin in 102 ethnic Turkish patients. Lab Med. (Among 102 Turkish patients with acne, ages 15 to 37 years, treated with oral isotretinoin for 24 weeks, mean ALT and AST values did not change, but instances of "Reference Change Values" were more frequent than in controls).
Guzman Rojas P, Gallegos Lopez R, Ciliotta Chehade A, Scavino Y, Morales A, Tagle M. (2016). Rev Gastroenterol Peru. (16 year old girl with acne developed serum enzyme elevations 3 months after starting isotretinoin [ALT 1196 U/L, Alk P 114, ANA 1:180] and improved with stopping isotretinoin and starting corticosteroid therapy).
DeKlotz CMC, Roby KD, Friedlander SF. (2017). Dietary supplements, isotretinoin, and liver toxicity in adolescents: a retrospective case series. Pediatrics. (Eight adolescents with acne in an isotretinoin monitoring program were found to have mild elevations in serum aminotransferase levels [ALT 34-59 U/L, AST 41-187 U/L, bilirubin normal and Alk P not provided], but all were also taking herbal and dietary supplements, including green tea, energy shakes and amino acids and creatine, and the elevations appeared to be more related to these products than the isotretinoin therapy).
Fox R, Stace N, Wood K, French C. Liver toxicity from vitamin A. JGH Open 2019; 4: 287-8. (27 year old female with acne who had received several six-month courses of isotretinoin in the past developed fatigue 18 months after starting vitamin A [bilirubin 0.9 mg/dL, ALT 15 U/L, Alk P 208 U/L], biopsy showing microvesicular fat and prominent stellate cells, with slow improvement after stopping).
Nazarian RS, Zheng E, Halverstam C, Cohen SR, Wolkoff AW. (2019). Prolonged serum alanine aminotransferase elevation associated with isotretinoin administration. Case Reports Hepatol. (16 year old teenage boy developed ALT elevations within 2 months of starting isotretinoin which continued to rise for the month after stopping [peak bilirubin 0.5 mg/dL, ALT 288 U/L, Alk P 153 U/L, INR 1.2], which improved on starting cholestyramine and eventually fell to baseline two months later; he later tolerated restarting isotretinoin without recurrence of liver injury).
Barbieri JS, Frieden IJ, Nagler AR. (2020). Isotretinoin, patient safety, and patient-centered care-time to reform iPLEDGE. JAMA Dermatol. (Viewpoint on the FDA program restricting use of isotretinoin and requiring rigorous monitoring for birth control mentions that pregnancy prevention programs are often ineffective but can be financially burdensome and interfere with appropriate therapy of severe acne; no discussion of ALT elevations or hepatotoxicity).
Bagatin E, Costa CS. (2020). The use of isotretinoin for acne - an update on optimal dosing, surveillance, and adverse effects. Expert Rev Clin Pharmacol. (Review of the literature on the efficacy and safety of isotretinoin concludes that it is highly effective in patients with severe acne and that its serious side effects can be effectively managed; ALT elevations generally arise during the first few months of therapy and often resolve even without discontinuation or dose modification).

## OTHER REFERENCE LINKS

1 Recent References on Isotretinoin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Isotretinoin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Isotretinoin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Isotretinoin)